# Reslizumab

## OVERVIEW

### Introduction

Reslizumab is a humanized monoclonal antibody to interleukin-5 (IL-5) which leads to a decrease in production and maturation of eosinophils and is used therapeutically to reduce allergic symptoms of asthma in patients with an eosinophilic phenotype. Reslizumab has not been associated with serum enzyme elevations during therapy or to instances of clinically apparent drug induced liver injury.

### Background

Reslizumab (res liz' ue mab) is a recombinant, humanized IgG4 monoclonal antibody to IL-5 which binds to the circulating cytokine and blocks its ability to cause maturation and proliferation of eosinophils. IL-5 is a cytokine growth and stimulating factor which has a selective role in recruiting eosinophils from the bone marrow and promoting their differentiation, activation and survival. Reslizumab lowers eosinophil counts in patients with hypereosinophilia as well as in normal, healthy controls. Therapy with reslizumab has been shown to reduce the requirement for inhaled corticosteroids and lower the frequency of exacerbations of eosinophilic asthma and other conditions associated with severe hypereosinophilia. Reslizumab was approved for use in the United States in 2016 for therapy of adult patients with severe eosinophilic asthma resistant to standard therapy with inhaled corticosteroids. Reslizumab is available in solution in single use vials of 100 mg in 10 mL (10 mg/mL) under the brand name Cinqair. The recommended dose is 3 mg/kg given intravenously over 20 to 30 minutes every 4 weeks. Side effects are not common, but can include injection site reactions, muscle pain, oropharyngeal pain, back pain, fatigue, nausea and creatine kinase (CK) elevations. Reslizumab can also cause severe hypersensitivity reactions including anaphylaxis, for which reason it should be administered in a health care setting and patients observed during and for a period of time after the infusion.

### Hepatotoxicity

In large clinical trials, reslizumab was not associated with changes in serum aminotransferase levels during therapy, and rates of most adverse reactions were similar in patients who received placebo injections or standard care. There have been no published reports of clinically apparent acute liver injury attributed to reslizumab therapy. Thus, liver injury from reslizumab must be rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Reslizumab is a humanized monoclonal antibody and is unlikely to be inherently hepatotoxic. Recombinant proteins are usually metabolized in the cells on which they act but are also metabolized in the liver, largely to small peptides and amino acids which may be reused to synthesize proteins and are unlikely to be toxic or immunogenic. Reslizumab lowers serum eosinophil counts, which seems to have no adverse effects on the liver and does not result in significant immunosuppression.

Drug Class: Antiasthmatic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Reslizumab – Cinqair®

DRUG CLASS

Antiasthmatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Reslizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Reslizumab | 241473-69-8 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 14 March 2017

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; "the biological immuno-suppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; reslizumab is not specifically mentioned).
Barnes PJ. Pulmonary pharmacology. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1031-65. (Textbook of pharmacology and therapeutics).
Rothenberg ME, Klion AD, Roufosse FE, Kahn JE, Weller PF, Simon HU, Schwartz LB, et al.; Mepolizumab HES Study Group. Treatment of patients with the hypereosinophilic syndrome with mepolizumab. N Engl J Med 2008; 358: 1215-28. (Among 84 patients with hypereosinophilic syndromes treated with mepolizumab or placebo intravenously every 4 weeks for 32 weeks, reduction in daily corticosteroid dose was more frequent with treatment and side effects were similar; while there were "no clinically relevant trends" in laboratory tests, one mepolizumab treated subject developed "hepatitis", but no details given). 18344568
Ogbogu PU, Bochner BS, Butterfield JH, Gleich GJ, Huss-Marp J, Kahn JE, Leiferman KM, et al. Hypereosinophilic syndrome: a multicenter, retrospective analysis of clinical characteristics and response to therapy. J Allergy Clin Immunol 2009; 124: 1319-25. e3. (Among 188 patients with hypereosinophilic syndrome seen at 11 referral centers in the US between 2001 and 2006, 55% were male, ages 6-85 [median=45] years, most responded to corticosteroids and resistant cases of therapy with monoclonal antibody to IL5). 19910029
Castro M, Mathur S, Hargreave F, Boulet LP, Xie F, Young J, Wilkins HJ, et al.; Res-5-0010 Study Group. Reslizumab for poorly controlled, eosinophilic asthma: a randomized, placebo-controlled study. Am J Respir Crit Care Med 2011; 184: 1125-32. (Among 106 patients with poorly controlled eosinophilic asthma treated with reslizumab or placebo injections every 4 weeks for 12 weeks, symptoms and pulmonary function improved more with reslizumab, adverse events rates were similar in the two groups, and there were "no clinically meaningful changes in laboratory values"). 21852542
Spergel JM, Rothenberg ME, Collins MH, Furuta GT, Markowitz JE, Fuchs G 3rd, O'Gorman MA, et al. Reslizumab in children and adolescents with eosinophilic esophagitis: results of a double-blind, randomized, placebo-controlled trial. J Allergy Clin Immunol 2012; 129: 456-63. (Among 226 children or adolescents with eosinophilic esophagitis treated with reslizumab [1, 2 or 3 mg/kg] or placebo every 4 weeks for 12 weeks, eosinophil counts in the esophagus decreased with reslizumab, but there were no differences in symptom scores or in adverse events between the two groups). 22206777
Gleich GJ, Klion AD, Lee JJ, Weller PF. The consequences of not having eosinophils. Allergy 2013; 68: 829-35. (Review data on patients treated with monoclonal antibody to IL5 for several years failed to show any identifiable, long term adverse effects of inhibition or decrease in eosinophil counts). 23742015
Hilvering B, Xue L, Pavord ID. Evidence for the efficacy and safety of anti-interleukin-5 treatment in the management of refractory eosinophilic asthma. Ther Adv Respir Dis 2015; 9: 135-45. (Review of the efficacy and safety of monoclonal anti-IL5 therapy in asthma; mentions that side effect rates are similar to those with placebo and neutralizing antibodies have not been a problem; no mention of ALT elevations or hepatotoxicity). 25900924
Castro M, Zangrilli J, Wechsler ME, Bateman ED, Brusselle GG, Bardin P, Murphy K, et al. Reslizumab for inadequately controlled asthma with elevated blood eosinophil counts: results from two multicentre, parallel, double-blind, randomised, placebo-controlled, phase 3 trials. Lancet Respir Med 2015; 3: 355-66. (Among 953 adults with poorly controlled eosinophilic asthma treated with reslizumab [3 mg/kg] or placebo injections every 4 weeks for one year, there was a 50% reduction in episodes of acute asthma with reslizumab, but side effects were similar in the two groups; no mention of ALT elevations or hepatotoxicity, but mention of two cases of anaphylaxis after reslizumab infusions). 25736990
Bjermer L, Lemiere C, Maspero J, Weiss S, Zangrilli J, Germinaro M. Reslizumab for inadequately controlled asthma with elevated blood eosinophil levels: a randomized phase 3 study. Chest 2016; 150: 789-98 (Among 315 patients with poorly controlled eosinophilic asthma treated with reslizumab [0.3 or 3 mg/kg] or placebo every 4 weeks for 16 weeks, reslizumab was associated with an improvement in FEV1 and asthma symptoms and slight increase in rates of headache, nausea and vomiting, but there were no treatment related serious adverse events and no mention of ALT elevations or hepatotoxicity). 27056586
Corren J, Weinstein S, Janka L, Zangrilli J, Garin M. Phase 3 study of reslizumab in patients with poorly controlled asthma: effects across a broad range of eosinophil counts. Chest 2016; 150: 799-810. (Among 492 patients with poorly controlled asthma treated with reslizumab [3 mg/kg] or placebo every 4 weeks for 16 weeks, beneficial effects were limited to patients with baseline eosinophilia above 400 cells/µL, and chemistry results "did not reveal any meaningful treatment effect"). 27018175
Mepolizumab (Nucala) for severe eosinophilic asthma. Med Lett Drugs Ther 2016; 58 (1486): 11-2. (Concise summary of the mechanism of action, clinical efficacy, safety and costs of mepolizumab shortly after its approval in the US for eosinophilic asthma; mentions side effects of headache, back pain, fatigue and infusion site reactions, but does not mention ALT elevations or hepatotoxicity). 26761344
Reslizumab (Cinqair) for severe eosinophilic asthma. Med Lett Drugs Ther 2016; 58 (1497): 81-2. (Concise summary of the mechanism of action, clinical efficacy, safety and costs of reslizumab shortly after its approval in the US; mentions side effects of oropharyngeal pain, CK elevations and myalgia and serious adverse events of anaphylaxis [0.3%] and malignancy, but does not mention ALT elevations or hepatotoxicity). 27305070
Nixon J, Newbold P, Mustelin T, Anderson GP, Kolbeck R. Monoclonal antibody therapy for the treatment of asthma and chronic obstructive pulmonary disease with eosinophilic inflammation. Pharmacol Ther 2017; 169: 57-77. (Review of the role of eosinophils in asthma and chronic obstructive lung disease and clinical efficacy of monoclonal antibodies to IL5 including reslizumab and mepolizumab). 27773786

## OTHER REFERENCE LINKS

1. Recent References on Reslizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Reslizumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Reslizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Reslizumab)